# Pembrolizumab

## OVERVIEW

### Introduction

Pembrolizumab is a humanized monoclonal antibody to programmed cell death receptor 1 (PD-1), which acts as a checkpoint inhibitor and is used in the immunotherapy of several forms of advanced or metastatic cancer. Pembrolizumab like other checkpoint inhibitors has major side effects and particularly immune related conditions, including acute hepatocellular and cholestatic liver injury which can be serious and even life threatening.

### Background

Pembrolizumab (pem" broe liz' ue mab) is a humanized recombinant monoclonal IgG4 kappa-isotype antibody to the programmed cell death receptor-1 (PD-1), which has distinctive immunomodulatory activity and is used as a checkpoint inhibitor in cancer immunotherapy. PD-1 is an important checkpoint molecule that modulates and down regulates T cell responses. Inhibition of PD-1 receptors on the surface of activated T cells prevents their binding to the PD receptor which activates pathways that terminate the activation and proliferation of T cells. Without the PD-1 receptor engagement, T cell responses remained activated. The subsequent enhancement of cytotoxic reactivity may play a beneficial role in cancer immunotherapy by breaking immunological tolerance to cancer cell neo-antigens. In several large multicenter studies, pembrolizumab therapy resulted in a prolongation of survival in patients with advanced, metastatic or unresectable malignant melanoma, and a proportion of patients had a long term remission. Pembrolizumab was approved for use in advanced melanoma in the United States in 2014 and subsequently for several other forms of advanced or metastatic cancer including non-small cell lung cancer (NSCLC), renal cell carcinoma, urothelial carcinoma, hepatocellular carcinoma, gastric and esophageal cancer, head and neck cancer, cervical and endometrial cancer, breast cancer, cutaneous squamous cell cancer and several forms of lymphoma. Pembrolizumab is available in 4 mL single use vials of 100 mg (25 mg/mL) under the brand name Keytruda. The typical regimen in adults is 200 mg as an intravenous infusion every 3 weeks or 400 mg every 6 weeks, but varies in children by body weight.

Side effects of pembrolizumab are common and can include fatigue, headache, musculoskeletal pain, arthralgia, abdominal pain, diarrhea, nausea, vomiting, decreased appetite, weight loss, fever, cough, dyspnea, pruritus, and rash. Importantly, as a result of immune enhancement, between 15% and 25% of pembrolizumab treated patients develop immune related side effects, including enterocolitis, dermatitis, endocrinopathy, pneumonitis, neuropathy, nephritis and hepatitis. Most of these reactions respond to immunosuppressive therapy, but some have resulted in fatalities and some have required permanent discontinuation of checkpoint inhibitor therapy and long term immunosuppressive therapy. These immune related adverse events are more frequent with combination therapy of ipilimumab and pembrolizumab. Baseline screening and regular monitoring for these adverse events during pembrolizumab therapy is recommended. Early recognition and prompt management of side effects is an integral component of proper use of checkpoint inhibitors. Checkpoints inhibitors should be used only by health care professional with training in immunotherapy and experience in the management of the side effects of immunomodulatory agents. Other rare but potentially severe adverse effects of pembrolizumab include infusion hypersensitivity reactions and embryo-fetal toxicity.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations are not uncommon (20% to 30%) during pembrolizumab therapy, but are usually self-limited and resolve even with continuing cyclic therapy. These rates of serum enzyme elevations are similar to those with other forms of chemotherapy for advanced malignancies. Serum ALT elevations above 5 times the upper limit of normal (ULN) occur in 1% to 4% of patients and generally lead to temporary discontinuation. Importantly, in 1% to 2% of patients the serum enzyme elevations evolve into an immune mediated liver injury that can be clinically apparent and can be severe. The onset of injury is usually after 2 to 4 cycles or 1 to 3 months after starting treatment. The pattern of enzyme elevation is usually hepatocellular but can be mixed or even cholestatic. Liver histology typically demonstrates a panlobular hepatitis with focal or confluent necrosis and prominent lymphocytic infiltrates of activated T cells, compatible with an immune mediated hepatic injury. More severe forms of hepatitis may demonstrate centrilobular (zone 3) necrosis. Despite features of immune mediated liver injury, autoantibodies are usually not present and immunoglobulin levels are normal. Because of the serious nature of the liver injury, monitoring with routine liver tests (including alkaline phosphatase) is recommended for patients who receive checkpoint inhibitor therapy. Treatment with corticosteroids generally results in a rapid improvement, allowing for their discontinuation within 1 to 2 months. In some instances, however, the clinical and biochemical response is inadequate, calling for addition of a second immunosuppressive agent such as azathioprine or mycophenolate mofetil. Restarting pembrolizumab or another checkpoint inhibitor after resolution of the hepatic injury is sometimes possible, but can result in recurrence of injury and has not been shown to improve outcome of the cancer chemotherapy.

A proportion of patients receiving pembrolizumab develop cholestatic rather than hepatocellular liver injury. Cholestatic forms of immune mediated liver injury generally arise later than the hepatocellular forms (after 3 to 10 cycles) and are often accompanied by abdominal pain and jaundice. Alkaline phosphatase levels are markedly elevated while aminotransferase levels are only modestly increased. Imaging studies may show irregular dilatation of the intra- and/or extra-hepatic bile ducts and thickening of the gall bladder and bile duct wall but without evidence of frank obstruction. Liver biopsy shows portal inflammation and bile duct injury, and endoscopic biopsy of bile duct epithelium shows inflammation and scarring. The general features suggest a secondary form of sclerosing cholangitis referred to as checkpoint inhibitor cholangiopathy. Therapy with immunosuppression may improve alkaline phosphatase and bilirubin levels but rarely leads to complete recovery, and long term cholestasis and hepatic failure can occur. Some patients with a cholestatic form of immune related liver injury do not manifest the large bile duct changes but demonstrate loss and paucity of the smaller intrahepatic bile ducts resulting in a vanishing bile duct syndrome similar to primary biliary cholangitis (PBC).

The effects of PD-1 inhibition on chronic hepatitis B are not well defined, but convincing examples of reactivation of hepatitis B have been described due to pembrolizumab and other checkpoint inhibitors. Most cases have occurred in patients with preexisting HBsAg, but rare instances were reported in individuals suspected of having with anti-HBc without HBsAg. Thus, screening patients for HBsAg, anti-HBc and anti-HBs is appropriate before initiating immunotherapy with checkpoint inhibitors. Patients with HBsAg should be considered for prophylaxis with an antiviral agent with potent activity against HBV such as entecavir or tenofovir. In patients with anti-HBc without HBsAg, monitoring and close attention to liver test abnormalities is probably adequate if antiviral therapy can be introduced rapidly for early evidence of reactivation. There has not been adequate experience with pembrolizumab in regard to the risk of reactivation of hepatitis B to provide rates of reactivation with and without antiviral prophylaxis.

Likelihood score: A (well known cause of clinically apparent liver injury and likely cause of reactivation of hepatitis B).

### Mechanism of Injury

The mechanism of liver injury due to pembrolizumab is likely to be immunologically mediated and is usually at least partially responsive to corticosteroid or immunosuppressive therapy. Liver biopsies in cases of hepatocellular injury and bile duct epithelial cell biopsies in cholangiopathic injury demonstrate necrosis and inflammatory cell infiltration with cytotoxic CD8+ T cells, suggesting that the checkpoint inhibition allowed for activation of T cells directed at hepatocyte or cholangiocyte cell surface antigens.

### Outcome and Management

Guidelines for management of patients receiving pembrolizumab recommend monitoring of liver tests and interrupting therapy for patients who develop serum aminotransferase elevations above 3 times the upper limit of normal (ULN), and discontinuing treatment for values above 8 times the ULN in patients without preexisting abnormalities or tumor involvement of the liver (in whom elevations of 5 and 10 times the ULN are used). Corticosteroid therapy can be considered for patients with high or persistent ALT elevations or if symptoms or jaundice arise, initiating therapy with high dose intravenous methylprednisolone and switching to oral prednisone after 1 to 2 days, continuing tapering doses for at least 30 days.

Most cases of hepatitis due to pembrolizumab resolve with prompt institution of immunosuppressive therapy which can be discontinued in 1 to 3 months. In some more protracted and resistant instances, corticosteroids have only a limited effect and adding a second agent is needed. Mycophenolate mofetil or azathioprine are most commonly recommended. Other immunosuppressive agents that have been reported to be beneficial include antithymocyte globulin, tacrolimus, infliximab and cycloserine. In refractory cases, immunosuppressive therapy may be needed long term. The few fatal cases due to checkpoint inhibitors have typically occurred in patients who have cholestatic forms of liver injury or have other severe immune related adverse events (Stevens Johnson syndrome, capillary leak syndrome). Restarting pembrolizumab after severe liver injury requiring corticosteroid therapy can be followed by recurrence of liver injury and is not recommended. Switching to other checkpoint inhibitors (ipilimumab or anti-PD-L1 inhibitors) is more likely to be tolerated. Interestingly, survival rates do not seem to be improved by re-introduction of checkpoint inhibitor therapy after severe immune related adverse events. Thus, restarting therapy should be undertaken only after careful evaluation of the residual cancer status.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies, Checkpoint Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pembrolizumab – Keytruda®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pembrolizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pembrolizumab | 1374853-91-4 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 23 June 2022

Abbreviations used: CPI, checkpoint inhibitor; CTLA-4, cytotoxic T lymphocyte associated antigen 4; HCC, hepatocellular carcinoma; irAE, immune related adverse event; PD-1, programmed cell death receptor 1; PD-L1, programmed cell death receptor ligand-1; NSCLC, non-small cell lung cancer; SCLC, small cell lung cancer.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/label/2020/125514s59-64,69,76-83SumR.pdf (FDA website with current and previous product labels and the 2014 initial medical review of the new drug application for pembrolizumab; ALT elevations arose in 26% [1% above 5 times ULN] and Alk P elevations in 27% [2% above 3 times ULN ).
Phan GQ, Yang JC, Sherry RM, Hwu P, Topalian SL, Schwartzentruber DJ, Restifo NP, et al. (2003). Cancer regression and autoimmunity induced by cytotoxic T lymphocyte-associated antigen 4 blockade in patients with metastatic melanoma. Proc Natl Acad Sci U S A. (Initial study of anti-CTLA-4 therapy in 14 patients with melanoma, 6 of whom developed clinically apparent immune adverse reactions including one with hepatitis arising after the third infusion [ALT 6820 U/L], resolving over the ensuing 4 months with corticosteroid therapy: Case 1).
Kleiner DE, Berman D. (2012). Pathologic changes in ipilimumab-related hepatitis in patients with metastatic melanoma. Dig Dis Sci. (Clinical and histological features of 5 patients with acute liver injury due to ipilimumab; 3 men and 2 women, ages 43 to 76 years, arising after 2-4 courses, 39-71 days after initial dose [peak bilirubin 1.5-5.1 mg/dL, ALT 326-3070 U/L, Alk P 206-427 U/L], only one had autoantibodies, resolving with immunosuppressive therapy within 1-4 months; one had recurrence on rechallenge; liver biopsies showed acute hepatitis usually with prominent inflammation, interface hepatitis and confluent necrosis: Case 1 Ipilimumab).
Topalian SL, Hodi FS, Brahmer JR, Gettinger SN, Smith DC, McDermott DF, Powderly JD, et al. (2012). Safety, activity, and immune correlates of anti-PD-1 antibody in cancer. N Engl J Med. (Among 296 patients with advanced cancers [melanoma, NSCLC, renal, prostate and colorectal] treated with 1 of 5 doses of nivolumab every 2 weeks, response rates were highest with melanoma and renal cancer, and drug related adverse events were common, including immune related conditions such as pneumonitis [3 fatal], vitiligo, colitis, hepatitis [reversible in all cases], hypophysitis and thyroiditis; ALT elevations occurred in 11 patients [4%] and were greater than 5 times ULN in 2 [1%]).
Brahmer JR, Tykodi SS, Chow LQ, Hwu WJ, Topalian SL, Hwu P, Drake CG, et al. (2012). Safety and activity of anti-PD-L1 antibody in patients with advanced cancer. N Engl J Med. (Among 207 patients with various advanced solid tumors treated with nivolumab given daily for 14 days in 6 week cycles for an average of 12 weeks, durable tumor regression occurred in 6-17% of patients; serious adverse events considered related to therapy occurred in 5%, but no patient had ALT elevations above 5 times ULN).
Gardiner D, Lalezari J, Lawitz E, DiMicco M, Ghalib R, Reddy KR, Chang KM, et al. (2013). A randomized, double-blind, placebo-controlled assessment of BMS-936558, a fully human monoclonal antibody to programmed death-1 (PD-1), in patients with chronic hepatitis C virus infection. PLoS One. (Among 56 patients with chronic hepatitis C treated with a single injection of nivolumab or placebo, decreases in HCV RNA occurred in 11% of both groups, 12% had immune related adverse events and one a transient ALT elevation above 10 times ULN).
Robert C, Ribas A, Wolchok JD, Hodi FS, Hamid O, Kefford R, Weber JS, et al. (2014). Anti-programmed-death-receptor-1 treatment with pembrolizumab in ipilimumab-refractory advanced melanoma: a randomized dose-comparison cohort of a phase 1 trial. Lancet. (Among 173 adults with advanced metastatic melanoma not responding to ipilimumab treated with pembrolizumab [2 or 10 mg/kg every 3 weeks], objective response rates were 26% at both doses; ALT elevations occurred in 3.5% of patients, but were below 5 times ULN; one patient developed “autoimmune hepatitis”, but no further information provided).
Teply BA, Lipson EJ. (2014). Identification and management of toxicities from immune checkpoint-blocking drugs. Oncology (Williston Park). (Clinical review of the toxicities of immune checkpoint blocking drugs such as ipilimumab, pembrolizumab and nivolumab; mentions that elevations of serum aminotransferase elevations should lead to careful exclusion of other causes of liver injury and increased monitoring; that elevations above 3 times ULN should lead to withholding the drug and starting corticosteroids; and, that elevations above 5 times ULN should lead to hospital admission and immediate administration of high doses of corticosteroids).
Tumeh PC, Harview CL, Yearley JH, Shintaku IP, Taylor EJ, Robert L, Chmielowski B, et al. (2014). PD-1 blockade induces responses by inhibiting adaptive immune resistance. Nature. (Analysis of expression of PD-1 and its ligand on CD8+ T cells at the margins of melanoma tumors before and after treatment with pembrolizumab showed that high levels of PD-1 and its ligand are found in responders to therapy).
(2014). Pembrolizumab (Keytruda) for metastatic melanoma. Med Lett Drugs Ther. (Concise review of the rationale, mechanism of action, efficacy, safety and cost of pembrolizumab as therapy for metastatic melanoma shortly after its approval in the US; mentions that immune related adverse events occur, but are uncommon and can include hepatitis).
Rizvi NA, Hellmann MD, Snyder A, Kvistborg P, Makarov V, Havel JJ, Lee W, et al. (2015). Cancer immunology. Mutational landscape determines sensitivity to PD-1 blockade in non-small cell lung cancer. Science. (Exome sequencing from NSCLC tumors in patients treated with pembrolizumab showed that patients with a durable clinical benefit of therapy typically had higher numbers of nonsynonymous mutations, an association confirmed in a second cohort; mutations were not in the known PD-1 or checkpoint pathways, but likely represented genes that express neo-antigens).
Sharma P, Allison JP. (2015). The future of immune checkpoint therapy. Science. (Commentary and review of the rationale, history, clinical efficacy and mechanism of action of immune checkpoint therapy).
Martin-Liberal J, Furness AJ, Joshi K, Peggs KS, Quezada SA, Larkin J. (2015). Anti-programmed cell death-1 therapy and insulin-dependent diabetes: a case report. Cancer Immunol Immunother. (54 year old woman with melanoma who was treated unsuccessfully with nivolumab and ipilimumab, developed diabetic ketoacidosis after 3 doses of pembrolizumab [anti-GAD positive] having had normal glucose levels before treatment, but also having high risk HLA alleles for type 1 diabetes; no mention of ALT elevations).
Hughes J, Vudattu N, Sznol M, Gettinger S, Kluger H, Lupsa B, Herold KC. (2015). Precipitation of autoimmune diabetes with anti-PD-1 immunotherapy. Diabetes Care. (Description of 5 patients with cancer who had new-onset of insulin dependent diabetes 1 week to 5 months after starting nivolumab [n=4] or pembrolizumab [n=1], 3 with anti-GAD, and all requiring insulin therapy chronically; 3% of patients treated with these agents at this cancer center).
Robert C, Schachter J, Long GV, Arance A, Grob JJ, Mortier L, Daud A, et al., KEYNOTE-006 investigators. (2015). Pembrolizumab versus ipilimumab in advanced melanoma. N Engl J Med. (Among 834 patients with advance melanoma treated with pembrolizumab [Pem: 10mg/kg every 2 or 3 weeks] or ipilimumab [Ipil: 3 mg/kg every 3 weeks], 6 month progression free survival was higher with Pem [47% and 46%] than Ipil [26.5%] and adverse events were less; thyroiditis was more common with Pem, whereas colitis and hypophysitis were more common with Ipil; ALT elevations occurred in 3% [Pem] vs 3.5% [Ipil] and were above 5 times ULN in 0.2% vs 0.8%).
Garon EB, Rizvi NA, Hui R, Leighl N, Balmanoukian AS, Eder JP, Patnaik A, et al. (2015). KEYNOTE-001 Investigators. Pembrolizumab for the treatment of non-small-cell lung cancer. N Engl J Med. (Among 495 patients with advanced NSCLC treated with pembrolizumab in 1 of 3 dose regimens, the overall response rate was 19% but was higher among those with greater PD-ligand 1 staring of tumor cells; adverse events occurred in 71%, including hypothyroidism 7%, pneumonitis 4% [1 fatal], and ALT elevations 2.2%).
Le DT, Uram JN, Wang H, Bartlett BR, Kemberling H, Eyring AD, Skora AD, et al. (2015). PD-1 blockade in tumors with mismatch-repair deficiency. N Engl J Med. (Among 41 patients with advanced cancers with or without mismatch repair deficiency, response rates to pembrolizumab were higher in those with mismatch repair deficiency [53%] than in those without [0%]; adverse events occurred in 98% of patients; ALT elevations occurred in 3 [7%] patients and were greater than 5 times ULN in 2 [5%]).
Ribas A, Puzanov I, Dummer R, Schadendorf D, Hamid O, Robert C, Hodi FS, et al. (2015). Pembrolizumab versus investigator-choice chemotherapy for ipilimumab-refractory melanoma (KEYNOTE-002): a randomised, controlled, phase 2 trial. Lancet Oncol. (Among 540 patients with advanced ipilimumab-refractory melanoma treated with pembrolizumab [2 or 10 mg/kg every 3 weeks] or standard chemotherapy, progression free survival at 6 months was greater with pembrolizumab and adverse events were less; ALT elevations occurred in 4 patients [1.1%] and were greater than 5 times ULN in 1 [0.3%]).
Abdel-Rahman O, El Halawani H, Fouad M. (2015). Risk of elevated transaminases in cancer patients treated with immune checkpoint inhibitors: a meta-analysis. Expert Opin Drug Saf. (Analysis of publications on checkpoint inhibitors indicated that therapy was associated with higher rates of ALT elevations).
Davar D, Wilson M, Pruckner C, Kirkwood JM. (2015). PD-1 blockade in advanced melanoma in patients with hepatitis C and/or HIV. Case Rep Oncol Med. (59 year old woman and 47 year old man with metastatic melanoma and combined HIV and hepatitis C infection were treated with pembrolizumab, tolerating therapy with no worsening of liver disease or HIV infection).
Hofmann L, Forschner A, Loquai C, Goldinger SM, Zimmer L, Ugurel S, Schmidgen MI, et al. (2016). Cutaneous, gastrointestinal, hepatic, endocrine, and renal side-effects of anti-PD-1 therapy. Eur J Cancer. (Among 496 patients with metastatic melanoma treated in 15 European centers with either nivolumab or pembrolizumab, 138 [28%] had at least one immune related adverse event including 11 [2%], with hepatitis arising after 1-4 infusions in all but 1, all treated with corticosteroids, 2 needing addition of mycophenolate, 9 resolving and 2 improving, none fatal).
Gelsomino F, Vitale G, D'Errico A, Bertuzzi C, Andreone P, Ardizzoni A. (2017). Nivolumab-induced cholangitic liver disease: a novel form of serious liver injury. Ann Oncol. (79 year old man with NSCLC developed jaundice after 4 infusions of nivolumab [day 62] with bilirubin 10.5, ALT ~480 U/L, Alk P~950 U/L, jaundice resolving 14 weeks after stopping therapy and with corticosteroid treatment, but patient died of progressive cancer shortly thereafter and before Alk P and GGT were completely normal).
Spänkuch I, Gassenmaier M, Tampouri I, Noor S, Forschner A, Garbe C, Amaral T. (2017). Severe hepatitis under combined immunotherapy: Resolution under corticosteroids plus anti-thymocyte immunoglobulins. Eur J Cancer. (49 year old woman with metastatic melanoma developed hepatitis after 3 cycles of ipilimumab and nivolumab [bilirubin 5.8 mg/dL, ALT 772 U/L, Alk P 449 U/L], with inadequate response to corticosteroids but eventual response after starting antithymocyte globulin, later tolerating pembrolizumab without recurrence on low doses of prednisone).
Kawakami H, Tanizaki J, Tanaka K, Haratani K, Hayashi H, Takeda M, Kamata K, et al. (2017). Imaging and clinicopathological features of nivolumab-related cholangitis in patients with non-small cell lung cancer. Invest New Drugs. (Among 91 Japanese patients with advanced NSCLC treated with nivolumab, 3 developed severe cholangitis arising after 6, 9 and 12 cycles in 2 women and 1 man, ages 64 to 82 years with marked elevations in Alk P (peak 1769, 1947 and 2996 U/L], modest ALT elevations [144, 101 and 70 U/L], no autoantibodies, and imaging showing localized common bile duct dilatation with distal breaking but no obstruction, hypertrophy of bile duct wall and no intrahepatic duct abnormalities, all with poor or only moderate response to corticosteroids).
Doherty GJ, Duckworth AM, Davies SE, Mells GF, Brais R, Harden SV, Parkinson CA, et al. (2017). Severe steroid-resistant anti-PD1 T-cell checkpoint inhibitor-induced hepatotoxicity driven by biliary injury. ESMO Open. (Three cases of checkpoint inhibitor induced cholestatic liver injury in 2 women and 1 man, ages 47, 59 and 76 years, who developed liver injury after 1-3 cycles of pembrolizumab or nivolumab, one with severe ductopenia who died of liver failure, one with focal ductopenia who eventually recovered, and one with prolonged cholestasis who died of progressive cancer, all with poor or only moderate response to corticosteroids).
Schachter J, Ribas A, Long GV, Arance A, Grob JJ, Mortier L, Daud A, et al. (2017). Pembrolizumab versus ipilimumab for advanced melanoma: final overall survival results of a multicentre, randomised, open-label phase 3 study (KEYNOTE-006). Lancet. (Among 811 patients with advanced melanoma treated with pembrolizumab [every 2 or 3 weeks] vs ipilimumab for a median of 23 months, overall survival at 24 months was higher with pembrolizumab [55% vs 42%] and serious adverse events were more frequent with ipilimumab, while hepatitis requiring drug discontinuation occurred only with pembrolizumab [4 cases: 0.7%, no deaths]).
Aivazian K, Long GV, Sinclair EC, Kench JG, McKenzie CA. (2017). Histopathology of pembrolizumab-induced hepatitis: a case report. Pathology. (67 year old man with metastatic melanoma and preexisting scleroderma developed fevers and jaundice shortly after an initial dose of pembrolizumab [bilirubin 23 mg/dL, ALT 117 U/L, Alk P 2275 U/L], with partial response to corticosteroids, but progression of melanoma leading to death a few months later, liver biopsy show focal and confluent necrosis, moderate inflammation, bile duct damage and cholestasis).
El-Khoueiry AB, Sangro B, Yau T, Crocenzi TS, Kudo M, Hsu C, Kim TY, et al. (2017). Nivolumab in patients with advanced hepatocellular carcinoma (CheckMate 040): an open-label, non-comparative, phase 1/2 dose escalation and expansion trial. Lancet. (Among 262 patients with advanced hepatocellular carcinoma [HCC] treated with nivolumab in dose escalation and expansion studies, objective responses were achieved in 15% to 20% of patients and toxicity was “manageable”, with ALT elevations in 15% that were above 5 times ULN in 6%; among 51 patients with HBV all were receiving antiviral prophylaxis and none had HBV reactivation).
Lake AC. (2017). Hepatitis B reactivation in a long-term nonprogressor due to nivolumab therapy. AIDS. (72 year old man with HIV infection, recurrent metastatic lung cancer and anti-HBc without HBsAg was started on dolutegravir and abacavir and then on nivolumab and was found to have acute liver injury 1 month later [bilirubin 0.5 mg/dL, ALT 332 UL, Alk P 205 U/L, HBsAg positive and HBV DNA > 170 million IU/mL], started on tenofovir and later tolerated restarting nivolumab).
Koksal AS, Toka B, Eminler AT, Hacibekiroglu I, Uslan MI, Parlak E. (2017). HBV-related acute hepatitis due to immune checkpoint inhibitors in a patient with malignant melanoma. Ann Oncol. (56 year old man with melanoma and HBsAg in serum developed liver injury 12 weeks after starting ipilimumab [bilirubin 0.7 rising to 1.9 mg/dL, ALT 246 rising to 888 U/L, HBV DNA 244,259 IU/mL], responding to tenofovir and was continued on nivolumab).
Ragunathan K, Dadana S, Huang C-H. (2017). Hepatitis B reactivation after administration of pembrolizumab (Keytruda): a unique case report. Amer J Gastroenterol. (51 year old man with metastatic lung cancer developed liver injury after 1^st^ dose of pembrolizumab and was found to have reactivation of HBV [bilirubin 0.8 mg/dL, ALT 615 U/L, Alk P 64 U/L, HBsAg positive, HBV DNA > 170 million IU/mL], no follow up provided [possibly same patient as in Pandey 2018]).
Pandey A, Ezemenari S, Liaukovich M, Richard I, Boris A. (2018). A rare case of pembrolizumab-induced reactivation of hepatitis B. Case Rep Oncol Med. (51 year old man with metastatic lung cancer developed liver injury after 1^st^ dose of pembrolizumab and was found to have reactivation of HBV [bilirubin normal, ALT 528 rising to 994 U/L, Alk P normal, HBsAg positive, HBeAg negative, HBV DNA > 170 million IU/mL], responding to tenofovir therapy, and later restarted on checkpoint inhibitor therapy).
Pollack MH, Betof A, Dearden H, Rapazzo K, Valentine I, Brohl AS, Ancell KK, et al. (2018). Safety of resuming anti-PD-1 in patients with immune-related adverse events (irAEs) during combined anti-CTLA-4 and anti-PD1 in metastatic melanoma. Ann Oncol. (Among 80 patients treated with checkpoint inhibitors who developed immune related adverse events requiring discontinuation who were then restarted on therapy, 31 [39%] had recurrence or toxicities requiring discontinuation again, of the 29 who had hepatitis initially, 5 had recurrence on restarting).
Santini FC, Rizvi H, Plodkowski AJ, Ni A, Lacouture ME, Gambarin-Gelwan M, Wilkins O, et al. (2018). Safety and efficacy of re-treating with immunotherapy after immune-related adverse events in patients with NSCLC. Cancer Immunol Res. (Among 482 patients with metastatic or advanced NSCLC treated with checkpoint inhibitors at a single US referral center between 2011 and 2016, 68 [14%] developed a serious immune related adverse event [irAE] that required discontinuation of whom 38 were retreated, of whom 18 had no recurrence, 10 had recurrence of the same irAE, 10 had a new irAE [2 of which were fatal]; restarting therapy appeared to be beneficial only in those who had no tumor response before onset of the first event).
Zen Y, Yeh MM. (2018). Hepatotoxicity of immune checkpoint inhibitors: a histology study of seven cases in comparison with autoimmune hepatitis and idiosyncratic drug-induced liver injury. Mod Pathol. (Liver histology from 7 patients with checkpoint inhibitor [CPI] induced hepatitis [4 nivolumab, 2 ipilimumab, arising after 1-6 doses] and classical autoimmune hepatitis showed similar rates of lobular hepatitis, but less confluent necrosis with CPIs and absence of autoantibodies and IgG elevations).
Huffman BM, Kottschade LA, Kamath PS, Markovic SN. (2018). Hepatotoxicity after immune checkpoint inhibitor therapy in melanoma: natural progression and management. Am J Clin Oncol. (Among 281 patients with cancer treated with checkpoint inhibitors at the Mayo Clinic over a 5 year period, 17 [6%] developed liver injury within 16 to 151 [median=52] days of starting [ipilimumab alone in 12, with nivolumab in 2 and pembrolizumab alone in 3], all with ALT elevations [59 to 2355 U/L], often with Alk P elevations [up to 1728 U/L], 6 with jaundice [bilirubin 2.5 to 15.7 mg/dL], all but one treated with corticosteroids, responding in 6 to 56 [median 31] days, 2 requiring a second agent [azathioprine or cycloserine], none fatal).
Postow MA, Sidlow R, Hellmann MD. (2018). Immune-related adverse events associated with immune checkpoint blockade. N Engl J Med. (Review of the clinical features, outcomes, pathogenesis and therapy of immune related adverse events of checkpoint inhibitor therapy).
De Martin E, Michot JM, Papouin B, Champiat S, Mateus C, Lambotte O, Roche B, et al. (2018). Characterization of liver injury induced by cancer immunotherapy using immune checkpoint inhibitors. J Hepatol. (Among 536 patients treated with checkpoint inhibitors, 19 [3.5%] were referred to a liver service for high grade hepatitis and 16 underwent liver biopsy; ages 33 to 84 years, 56% female, injury arising after 1-36 [median=5] weeks and 1-36 [median=2] doses, presenting with fever in 38%, rash in 31%, ALT 266 to 3137 [460] U/L, Alk P 54 to 768 [309] U/L, bilirubin 0.4 to 19 [1.1] mg/dL, enzyme pattern most commonly being mixed, 10 patients treated with corticosteroids and 6 resolving spontaneously and no deaths).
Karamchandani DM, Chetty R. (2018). Immune checkpoint inhibitor-induced gastrointestinal and hepatic injury: pathologists' perspective. J Clin Pathol. (Review of the gastrointestinal and hepatic pathology of checkpoint inhibitor induced immune adverse events with acute hepatitis and acute cholangitic patterns found on liver biopsy).
LoPiccolo J, Brener MI, Oshima K, Lipson EJ, Hamilton JP. (2018). Nodular regenerative hyperplasia associated with immune checkpoint blockade. Hepatology. (35 year old man with melanoma developed anasarca and ascites 3 weeks after starting pembrolizumab [bilirubin 0.8 mg/dL, ALT 62 U/L, Alk P 331 U/L, albumin 2.5 g/dL, INR 1.2], liver biopsy demonstrating nodular regenerative hyperplasia without fibrosis, and after stopping therapy and transjugular intrahepatic portosystemic stent shunt [TIPSS], the ascites and anasarca resolved).
Abu-Sbeih H, Tran CN, Ge PS, Bhutani MS, Alasadi M, Naing A, Jazaeri AA, et al. (2019). Case series of cancer patients who developed cholecystitis related to immune checkpoint inhibitor treatment. J Immunother Cancer. (Among 4253 patients treated with checkpoint inhibitors at the MD Anderson Cancer Center between 2010 and 2018, 25 [0.6%] developed acalculous cholecystitis attributed to the immunotherapy most frequently with anti-CTLA-4 agents alone [1.6%], than anti-PD1/PD-L1 [0.4%] and combination [0.9%], mean age of patients was 60 years, 60% male, 64% white, median peak ALT 55 U/L, bilirubin 1.4 mg/dL, 20% underwent cholecystectomy, all recovered, 10 [40%] restarted therapy, all without recurrence).
Fouchard M, Jantzem H, Quere G, Descourt R, Robinet G, Poureau PG. (2019). Three cases of immune cholangitis related to anti-programmed cell death and programmed cell death ligand agents for the treatment of non-small cell lung cancer. Eur J Cancer. (3 patients with metastatic lung cancer developed cholangitis 2, 4 and 9 months after starting checkpoint inhibitor therapy [nivolumab, durvalumab/tremelimumab, pembrolizumab] presenting with abdominal pain and fever, modest ALT but marked Alk P elevations and minimal jaundice, imaging showing biliary dilation and thickening of the gallbladder wall, biopsies showing inflammation with CD8+ lymphocytes, and slow clinical response to corticosteroids but long term remission in cancer).
Kurokawa K, Hara M, Iwakami SI, Genda T, Iwakami N, Miyashita Y, Fujioka M, et al. (2019). Cholestatic liver injury induced by pembrolizumab in a patient with lung adenocarcinoma. Intern Med. (48 year old man with refractory lung cancer developed fever, fatigue and jaundice 11 days after a second dose of pembrolizumab [bilirubin 5.4 mg/dL, ALT 175 U/L, Alk P 1033 U/L], with improvement on treatment with corticosteroids and ursodiol but death within months from progressive cancer).
Jennings JJ, Mandaliya R, Nakshabandi A, Lewis JH. (2019). Hepatotoxicity induced by immune checkpoint inhibitors: a comprehensive review including current and alternative management strategies. Expert Opin Drug Metab Toxicol. (Comprehensive review of the clinical features, diagnosis, histology, outcomes and management of checkpoint inhibitor related liver injury including serum aminotransferase elevations and immune related hepatic injury, with recommendations on use of corticosteroids based upon the grade of liver injury).
Kwan JM, Cheng R, Feldman LE. (2019). Hepatotoxicity and recurrent NSTEMI while on pembrolizumab for metastatic giant cell bone tumor. Am J Med Sci. (71 year old woman with metastatic giant cell tumor of the bone developed two episodes of chest pain and coronary occlusion and liver injury one year after starting pembrolizumab [bilirubin 6.2 rising to 13 mg/dL, ALT 463 U/L, Alk P 794 U/L], biopsy showing primary biliary cholangitis [Alk P had been elevated chronically] and an eosinophilic hepatitis, responding to prednisone and ursodiol).
Koya Y, Shibata M, Shinohara N, Nebuya S, Oe S, Honma Y, Senju M, et al. (2019). Secondary sclerosing cholangitis with hemobilia induced by pembrolizumab: Case report and review of published work. Hepatol Res. (66 year old man with small cell lung cancer developed cholestatic liver injury after 5 cycles of pembrolizumab [bilirubin 1.1 rising to 20 mg/dL, ALT 313 U/L, Alk P 2241 U/L], imaging showing dilatation of intra- and extra-hepatic bile ducts, biopsies showing secondary sclerosing cholangitis and active inflammation and scarring of bile ducts; only modest response to ursodiol, bezafibrate and corticosteroid therapy).
Kida A, Matsuda K, Matsuda M, Sakai A. (2019). Hepatobiliary and Pancreatic: Biliary injury related to checkpoint inhibitor "pembrolizumab". J Gastroenterol Hepatol. (62 year old man with ureteral carcinoma developed abdominal pain after starting pembrolizumab [bilirubin 0.6 mg/dL, ALT 306 U/L, GGT 581 U/L], with normal cholangiograms and liver biopsy showing portal inflammation and bile duct injury, responding to oral prednisone and restarted on pembrolizumab).
Cheung V, Gupta T, Payne M, Middleton MR, Collier JD, Simmons A, Klenerman P, et al. (2019). Immunotherapy-related hepatitis: real-world experience from a tertiary centre. Frontline Gastroenterol. (Among 453 patients treated with checkpoint inhibitors for cancer between 2022 and 2018, 20 [4%] developed immune related hepatitis, with highest rates with the combination of ipilimumab and nivolumab, 18 treated with immunosuppression using corticosteroids, 8 with addition of mycophenolate and 2 with infliximab, none fatal).
Zen Y, Yeh MM. (2019). Checkpoint inhibitor-induced liver injury: A novel form of liver disease emerging in the era of cancer immunotherapy. Semin Diagn Pathol. (Liver histology from 7 patients with checkpoint inhibitor [CPI] induced hepatitis [4 nivolumab, 2 ipilimumab, arising after 1-6 doses] and classical autoimmune hepatitis showed similar rates of lobular hepatitis, but less confluent necrosis with CPIs and absence of autoantibodies and IgG elevations).
Vozy A, De Martin E, Johnson DB, Lebrun-Vignes B, Moslehi JJ, Salem JE. (2019). Increased reporting of fatal hepatitis associated with immune checkpoint inhibitors. Eur J Cancer. (Review of the VigiBase registry of adverse drug reactions through September 2018 identified 531 cases of immune related hepatitis, 85% due to CPIs alone with an increase in fatality rate over time, being 14% between 2011 to 2016 and 34% in 2017-2018, time to onset median of 42 days, arising after 1-4 courses [median 2] and with concurrent other organ immune related injury in 31%, usually thyroid or skin).
Zhang D, Hart J, Ding X, Zhang X, Feely M, Yassan L, Alpert L, et al. (2019). Histologic patterns of liver injury induced by anti-PD-1 therapy. Gastroenterol Rep (Oxf). (Liver histology in 8 cases of immune mediated liver injury after monoclonal anti-PD1 therapy revealed a lobular hepatitis without features of autoimmune hepatitis).
Imoto K, Kohjima M, Hioki T, Kurashige T, Kurokawa M, Tashiro S, Suzuki H, et al. (2019). Clinical features of liver injury induced by immune checkpoint inhibitors in Japanese patients. Can J Gastroenterol Hepatol. (Among 343 Japanese patients with cancer treated with checkpoint inhibitors, 56 [16%] developed evidence of liver injury, arising after 21-94 [median=46] days, with initial ALT 39 to 136 [mean 60] U/L, Alk P 263 to 857 [471] U/L, bilirubin 0.4 to 1.0 [0.7] mg/dL, and thus a cholestatic pattern was found in most patients, and there was a low rate of high grade liver injury [3.2%] and no fatalities).
Zhang X, Zhou Y, Chen C, Fang W, Cai X, Zhang X, Zhao M, et al. (2019). Hepatitis B virus reactivation in cancer patients with positive Hepatitis B surface antigen undergoing PD-1 inhibition. J Immunother Cancer. (Among 114 HBsAg-positive Chinese patients undergoing checkpoint inhibitor therapy for advanced malignancies, 6 developed HBV reactivation [1 of 85 on prophylaxis vs 5 of 29 not] after 3-35 [median 18] weeks of therapy with peak ALT 28 to 465 U/L, HBV DNA 1,800 to 60 million IU/mL [all were undetectable at baseline], none with jaundice, 5 treated with rapid improvement, all 6 recovered).
Lee PC, Chao Y, Chen MH, Lan KH, Lee IC, Hou MC, Huang YH. (2020). Risk of HBV reactivation in patients with immune checkpoint inhibitor-treated unresectable hepatocellular carcinoma. J Immunother Cancer. (Among 62 Taiwanese patients with HBsAg or anti-HBc without HBsAg treated with checkpoint inhibitors for advanced HCC, reactivation of HBV rose in none of 56 given prophylaxis vs 1 of 6 not given antiviral prophylaxis: the one case in an HBsAg positive patient with HBV DNA 8960 IU/mL at baseline rising to 168,000 IU/mL, peak ALT 174U/L, bilirubin 5.2 mg/dL, resolving with tenofovir therapy).
Onoyama T, Takeda Y, Yamashita T, Hamamoto W, Sakamoto Y, Koda H, Kawata S, et al. (2020). Programmed cell death-1 inhibitor-related sclerosing cholangitis: a systematic review. World J Gastroenterol. (Review of literature on secondary sclerosing cholangitis due to anti-PD-1/PD-L1 therapy identified 31 cases with male:female ratio of 2:1, median age 67 [range 43 to 89] years, arising after a median of 5.5 [range 1-27] cycles of nivolumab [19], pembrolizumab [10], avelumab [1], or durvalumab [1], with median bilirubin 0.8 [0.3-15.9] mg/dL, ALT 125 [31-1536] U/L, AST 129 [49-961] U/L, Alk P 1543 [237-5066] U/L, GGT 452 [114-2094] U/L, cholangiography demonstrating biliary dilation without obstruction [77%], hypertrophy of the extrahepatic biliary tree [90%], and biliary strictures [30%] and biopsy demonstrating CD8+ infiltrates around bile ducts, and adequate response to corticosteroids in only 11%).
Zen Y, Chen YY, Jeng YM, Tsai HW, Yeh MM. (2020). Immune-related adverse reactions in the hepatobiliary system: second-generation check-point inhibitors highlight diverse histological changes. Histopathology. (Description of 10 cases of second generation checkpoint inhibitor induced immune liver injury mentions 3 patterns, hepatocellular, cholestatic and granulomatous injury, the cholestatic form often with a delayed latency and poor response to corticosteroids).
Peeraphatdit TB, Wang J, Odenwald MA, Hu S, Hart J, Charlton MR. (2020). Hepatotoxicity from immune checkpoint inhibitors: a systematic review and management recommendation. Hepatology. (Review of the clinical features, biochemical findings, histology, pathogenesis, diagnosis and management of immune related liver injury due to the checkpoint inhibitors).
Miller ED, Abu-Sbeih H, Styskel B, Nogueras Gonzalez GM, Blechacz B, Naing A, et al. (2020). Clinical characteristics and adverse impact of hepatotoxicity due to immune checkpoint inhibitors. Am J Gastroenterol. (Among 5762 recipients of checkpoint inhibitor therapy of cancer at the MD Anderson Cancer Center between 2010 and 2018, 433 [8%] developed ALT levels and 100 had levels above 5 times ULN [2%), the rate being 8% with combination therapy, 1.7% with anti-CTLA agents and 1.1% with PD1 and PDL1 blockers, the abnormalities arising after a median of 59 days; all had the checkpoint inhibitor therapy held, 67 received corticosteroids [for a median of 43 days], 3 with mycophenolate, and 31 were rechallenged after resolution of the hepatitis, of whom 8 [26%] had a recurrence).
Sawada K, Hayashi H, Nakajima S, Hasebe T, Fujiya M, Okumura T. (2020). Non-alcoholic fatty liver disease is a potential risk factor for liver injury caused by immune checkpoint inhibitor. J Gastroenterol Hepatol. (Among 135 patients with cancer treated with nivolumab or pembrolizumab, 8 developed immune mediated hepatitis of whom 3 [37.5%] had preexisting chronic liver disease versus 14 of the total [10.3%]).
Kitagataya T, Suda G, Nagashima K, Katsurada T, Yamamoto K, Kimura M, Maehara O, et al. (2020). Prevalence, clinical course, and predictive factors of immune checkpoint inhibitor monotherapy-associated hepatitis in Japan. J Gastroenterol Hepatol. (Among 202 patients with cancer treated with checkpoint inhibitors at a single referral center in Japan, 17 [8.5%] developed immune related hepatitis which was severe in 8 [4.5%] often requiring corticosteroids, 2 receiving mycophenolate as well, but none died).
Thorsteinsdottir T, Løitegård T, Reims HM, Porojnicu AC. (2020). Fatal cholestatic liver injury during treatment with PD1 immune checkpoint inhibitor for malignant melanoma: A Case Report. Case Rep Oncol. (70 year old woman with metastatic melanoma developed jaundice after 13 cycles of pembrolizumab [bilirubin 12.6 rising to 32.7 mg/dL, ALT 1536 U/L, GGT 2094 U/L, Alk P 237 U/L], biopsy showing few bile ducts, mild inflammation and marked cholestasis, with minimal response to corticosteroids and ursodiol, dying 26 days after symptom onset).
Ruggiero R, Fraenza F, Scavone C, di Mauro G, Piscitelli R, Mascolo A, Ferrajolo C, et al. (2020). Immune checkpoint inhibitors and immune-related adverse drug reactions: data from Italian Pharmacovigilance Database. Front Pharmacol. (Among 2088 safety reports of check point inhibitors enrolled in an Italian pharmacovigilance registry, 801 were immune related including gastrointestinal [33%], skin [17%] and liver [2.7%] due to nivolumab [70%], pembrolizumab [11%], ipilimumab [15%], atezolizumab [4%] and avelumab [<1%]).
Riveiro-Barciela M, Barreira-Díaz A, Vidal-González J, Muñoz-Couselo E, Martínez-Valle F, Viladomiu L, Mínguez B, et al. (2020). Immune-related hepatitis related to checkpoint inhibitors: clinical and prognostic factors. Liver Int. (Among 414 patients treated with checkpoint inhibitors, 28 developed high grade liver injury but 19 were considered mild, 7 moderate, 1 severe, and only 1 fatal).
Vitale G, Lamberti G, Comito F, Di Nunno V, Massari F, Morelli MC, Ardizzoni A, et al. (2020). Anti-programmed cell death-1 and anti-programmed cell death ligand-1 immune-related liver diseases: from clinical pivotal studies to real-life experience. Expert Opin Biol Ther. (Review of the hepatic complications of anti-PD-1 and anti-PD-L1 checkpoint inhibitors that includes immune mediated hepatitis [typically panlobular inflammation and injury], small and large duct cholangitis [similar to primary biliary and sclerosing cholangitis], immune mediated cholecystitis, nodular regenerative hyperplasia and vanishing bile duct syndrome).
Kitagataya T, Suda G, Nagashima K, Katsurada T, Yamamoto K, Kimura M, Maehara O, et al. (2020). Prevalence, clinical course, and predictive factors of immune checkpoint inhibitor monotherapy-associated hepatitis in Japan. J Gastroenterol Hepatol. (Among 202 patients with cancer treated with checkpoint inhibitors at a single referral center in Japan, 17 [8.5%] developed immune related hepatitis which was severe in 8 [4.5%], often requiring corticosteroids, 2 receiving mycophenolate as well, but none died).
Mizuno K, Ito T, Ishigami M, Ishizu Y, Kuzuya T, Honda T, Kawashima H, et al. (2020). Real world data of liver injury induced by immune checkpoint inhibitors in Japanese patients with advanced malignancies. J Gastroenterol. (Among 546 patients with advanced malignancies treated with checkpoint inhibitors at two Japanese referral centers between 2014 and 2019, high grade, immune mediated liver injury occurred in 29 [5%], mean age 69 years, 73% male, mean onset 52 [range 1-273] days, after 3 [1-15] doses of ipilimumab [6%], nivolumab [54%], pembrolizumab [30%], atezolizumab [6%], durvalumab [2.4%], combination [1.3%], presenting with hepatocellular [21%], cholestatic [59%] or mixed [21%] enzyme elevations, 4 with cholangitis and biliary dilatation without obstruction, only 1 case fatal; predictive factors for injury included ipilimumab [hazard ratio 4.2]).
Cho YA, Han JM, Kang SY, Kim DC, Youn YJ, Choi KH, Gwak HS. (2021). Analysis of risk factors for hepatotoxicity induced by immune checkpoint Inhibitors. J Immunother. (Among 194 patients with cancer treated with checkpoint inhibitors at two Korean referral centers, 125 [64%] developed liver test abnormalities, more frequently in younger patients vs older [30 to 50 years - 80% vs 50 to 70 years - 72%, and >70 years - 50%] and in men than women [68% vs 58%]).
Gauci ML, Baroudjian B, Bédérède U, Zeboulon C, Delyon J, Allayous C, Madelaine I, et al., PATIO group. (2021). Severe immune-related hepatitis induced by immune checkpoint inhibitors: Clinical features and management proposal. Clin Res Hepatol Gastroenterol. (Among 339 patients treated at a single French referral center with checkpoint inhibitors, 21 [6.2%] developed high grade liver toxicity, including 8% [7/86] receiving ipilimumab, 3% [3/105] nivolumab, 1% [1/122] pembrolizumab, and 38% [10/26] combination therapy; 13 patients received corticosteroids, all except one with severe biliary lesions recovered, and 8 restarted therapy none of whom relapsed).
Chatterjee A, Bivas BK, Gehani A, Sen S. (2021r). Pembrolizumab-induced large duct cholangiopathy: Diagnosis and follow-up imaging. J Postgrad Med. (66 year old man with lung cancer developed liver test abnormalities after two cycles of pembrolizumab [ALT 85 U/L, Alk P 232 subsequently rising to 1843 U/L], with imaging showing bile duct dilatation, which improved but not completely with holding pembrolizumab which was later restarted without worsening of the liver abnormalities).
Ortland I, Mirjalili M, Kullak-Ublick GA, Peymani P. (2021). Drug-induced liver injury in Switzerland: an analysis of drug-related hepatic disorders in the WHO pharmacovigilance database VigiBase™ from 2010 to 2020. Swiss Med Wkly. (Among 2042 cases of drug induced liver injury reported from Switzerland to VigiBase between 2010 and 2020, average age 57 years, males and females similar proportions, 10% were fatal and the most common causes included acetaminophen [5.8%], amoxicillin/clavulanate 3.1%, esomeprazole [2.0%], atorvastatin [1.9%], and nivolumab [1.3%]).
Yamamoto A, Yano Y, Ueda Y, Yasutomi E, Hatazawa Y, Hayashi H, Yoshida R, et al. (2021). Clinical features of immune-mediated hepatotoxicity induced by immune checkpoint inhibitors in patients with cancers. J Cancer Res Clin Oncol. (Among 250 patients with cancer treated with checkpoint inhibitors, 21 [9.5%] developed immune mediated liver injury, most frequently with ipilimumab [60%], ipilimumab and nivolumab [57%] compared to nivolumab alone [7%] or pembrolizumab [3%], and rates were higher in patients with melanoma [35%] compared to renal cell cancer [10%] and others).
Aya F, González-Navarro EA, Martínez C, Carcelero E, Arance A. (2021). Safe anti-programmed cell death-1 rechallenge with antibody switching after immune-related adverse events: brief communication. Immunotherapy. (68 year old woman with metastatic melanoma developed ALT elevations [215 U/L] after an initial dose of nivolumab, which resolved rapidly with prednisone therapy and she later tolerated pembrolizumab without recurrent hepatic injury).
da Silva JA, Falcão D, Cardoso C, Pires AL, Araújo A, Castro-Poças F. (2021). Hepatic immune-mediated adverse effects of immune checkpoint inhibitors: analysis of real-life experience. Ann Hepatol. (Among 151 patients treated with checkpoint inhibitors, 8 [5%] developed liver injury, 5 due to metastases and 3 from immune mediated hepatitis, 2 from nivolumab and 1 pembrolizumab, with latency of 84 days, all three cholestatic and responding to immunosuppression).
Suda T, Kobayashi M, Kurokawa K, Matsushita E. (2021). Simultaneous occurrence of autoimmune pancreatitis and sclerosing cholangitis as immune-related adverse events of pembrolizumab. BMJ Case Rep. (57 year old man with metastatic lung cancer developed evidence of liver injury 6 weeks after starting pembrolizumab, paclitaxel and carboplatin [ALT 84 U/L, Alk P 490 U/L]; pembrolizumab was continued but several weeks later he developed severe abdominal pain and pancreatitis [bilirubin 1.1 mg/dL, ALT 406 U/L, Alk P 1330 U/L, amylase 1034 U/L], cholangiography showing irregularities of intrahepatic bile ducts and biliary tree hypertrophy, responding slowly and only partially to high dose corticosteroids and ursodiol).
Wong GL, Wong VW, Hui VW, Yip TC, Tse YK, Liang LY, Lui RN, et al. (2021). Hepatitis flare during immunotherapy in patients with current or past hepatitis B virus infection. Am J Gastroenterol. (Among 990 patients in Hong Kong with advanced malignancies treated with checkpoint inhibitors between 2014 and 2019 [397 HBsAg positive, 482 with anti-HBc or anti-HBs, 111 negative for both at baseline], 39% of HBsAg-positive vs 30% of HBsAg-negative patients developed ALT elevations during therapy, but only two cases [both HBsAg positive and on prophylaxis] were due to HBV reactivation).
Mustafayev K, Torres H. Hepatitis B virus and hepatitis C virus reactivation in cancer patients receiving novel anticancer therapies. Clin Microbiol Infect. 2022: S1198-743X (22)00119-7. (Review of the literature on reactivation of HBV and HCV in patients on “novel” anticancer therapy concludes that reactivation can occur with checkpoint inhibitor therapy, but largely among HBsAg positive patients and only rarely in patients with resolved hepatitis B).
Yoo S, Lee D, Shim JH, Kim KM, Lim YS, Lee HC, Yoo C, et al. (2022). Risk of hepatitis B virus reactivation in patients treated with immunotherapy for anti-cancer treatment. Clin Gastroenterol Hepatol. (Among 3,465 patients with advanced malignancies treated with checkpoint inhibitors between 2015 and 2020 at a single referral center in Korean, 511 [15%] were HBsAg positive at baseline, reactivation of HBV occurred in 5 of 511 [1%] HBsAg positive vs none of 2,954 HBsAg negative patients, arising in 2 of 464 [0.4%] patients given prophylaxis [both having stopped antivirals] vs 3 of 47 not given prophylaxis [6.4%]; reactivation arising after 3-141 weeks [median 54 weeks] of nivolumab [n=2], pembrolizumab [n=2] or ipilimumab and nivolumab [n=1] treatment, ALT peak 53 to 1768 IU/mL, HBV DNA 6,100 to 3.9 million IU/mL, resolving with 2 to 6 weeks of starting antiviral therapy).
Al-Nattah S, Lata Sharma K, Caldis M, Spengler E, Nicholas Rose W. (2022). Plasmapheresis for pembrolizumab-induced hepatitis in a patient with squamous cell carcinoma and prior orthotopic liver transplantation. Case Reports Hepatol. (76 year old man with liver transplant for alcoholic cirrhosis with excellent control with tacrolimus developed refractory metastatic laryngeal carcinoma and was treated with pembrolizumab and 5 weeks later developed evidence of liver injury [bilirubin 2.1 mg/dL, ALT 783 U/L, Alk P 444 U/L], with minimal response to increases in immunosuppression and liver biopsy showing bile duct loss, thereafter treated with plasmapheresis and intravenous immunoglobulin with slow, eventual improvement).
Fernández-Gordón Sánchez FM, Gómez-Domínguez E, Paredes Ruiz D, Rodríguez Gil Y, Martín Algíbez A, Fernández Vázquez I, Martínez Montiel P. (2022). Ustekinumab for corticodependent immune-mediated colitis by pembrolizumab, an alternative for patients with concomitant liver injury. Rev Esp Enferm Dig. (56 year old woman with large cell lung cancer developed immune mediated colitis and cholestatic liver injury while receiving pembrolizumab that was successfully treated with corticosteroids and ustekinumab).

## OTHER REFERENCE LINKS

1 Recent References on Pembrolizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pembrolizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pembrolizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pembrolizumab)